# Daclizumab

## OVERVIEW

### Introduction

Daclizumab is a humanized monoclonal antibody to CD25, the alpha subunit of the IL2 receptor on T lymphocytes, which was used in the past to treat and prevent acute cellular rejection after solid organ transplantation and as a second line therapy of refactory relapsing multiple sclerosis. Daclizumab has been linked to mild-to-moderate serum enzyme elevations during therapy, and to rare but sometimes severe and fatal instances of immune mediated, clinically apparent liver injury for which reason it is no longer used.

### Background

Daclizumab (da kliz’ ue mab) is a humanized monoclonal immunoglobulin G1 antibody to the alpha subunit (CD25) of the high-affinity IL2 receptor which is highly expressed on activated T lymphocytes and regulatory T cells. Engagement of this IL2 receptor by daclizumab results in inhibition of proliferation of activated T lymphocytes and secretion of proinflammatory cytokines. Daclizumab has been shown to be effective in reducing in incidence of acute rejection after renal, liver, heart and lung transplantation. Daclizumab was approved for use in preventing acute rejection after renal transplantation in 1997 and was used largely as a part of induction regimens at and around the time of transplant. However, daclizumab was subsequently withdrawn by the sponsor in 2007 because of market factors rather than toxicity or lack of efficacy. Subsequently daclizumab was evaluated as therapy of several autoimmune conditions and was shown to decrease relapses in patients with refractory, relapsing multiple sclerosis. Daclizumab was reintroduced in 2016 with indications being second line therapy for refractory multiple sclerosis. Daclizumab was available in liquid solution in single use syringes or autoinjectors of 150 mg (150 mg/mL) under the brand name Zinbryta. The recommended dose was 150 mg subcutaneously once monthly. Side effects of daclizumab when used as therapy of multiple sclerosis included infusion reactions, chills, fever, skin rash, fatigue, leukopenia and infections. Less common, but potentially severe adverse events include immune mediated disorders, hepatitis, liver failure, severe infections, depression, suicidal ideation and hypersensitivity reactions including anaphylaxis, side effects that ultimately led to its withdrawal from clinical use in 2018.

### Hepatotoxicity

When given as a part of induction therapy for solid organ transplantation, daclizumab was not linked to instances of serum enzyme elevations or clinically apparent liver injury. While adverse events at the time of organ transplantation are common, they were not found to be more frequent in patients receiving induction therapy with daclizumab than in those given conventional immunosuppressive regimens.

In contrast, in studies of long term daclizumab therapy for autoimmune conditions such as multiple sclerosis, transient and asymptomatic elevations of serum aminotransferase levels were reported in up to one third of patients, and rose to above 5 times ULN in 4% to 6% of daclizumab vs 1% of placebo and 3% of interferon beta treated subjects. These serum enzyme elevations were usually transient and asymptomatic, but in rare instances led to jaundice and symptomatic acute liver injury. In preregistration clinical trials, 0.3% of patients treated with daclizumab for more than 6 months developed hepatitis with autoimmune features, and at least one patient died despite discontinuation of the monoclonal antibody therapy. The onset of the clinically apparent liver injury was usually within 1 to 6 months after starting the monthly injections, but some cases arose shortly after discontinuation of treatment. The clinical features of the liver injury suggested an immune mediated hepatitis with marked elevations in serum aminotransferase levels sometimes accompanied by autoantibody formation, increased immunoglobulin levels or liver biopsy histology demonstrating acute hepatocellular injury with lymphocytic infiltrates including plasma cells. Because of these reports, daclizumab product labels include a black box warning about hepatic injury, recommend prospective monitoring before, during and for several months after treatment, and state that daclizumab is contraindicated in patients with preexisting liver disease. Because of increasing number of reports of serious liver injury including deaths as well as serious inflammatory brain disorders and infections identified in extended studies of its use, daclizumab was withdrawn from clinical use in 2018.

Likelihood score: B (likely cause of clinically apparent liver injury).

Daclizumab is a potent immunosuppressive agent and may be capable of causing reactivation of chronic hepatitis B. However, its use in prevention of organ rejection as well as therapy of refractory multiple sclerosis has not been linked to cases of reactivation. In trials of daclizumab in multiple sclerosis and uveitis, cases of reactivation of hepatitis B or worsening of hepatitis C were not reported, but patients with coexisting hepatitis B or C were typically excluded from early phase trials.

Drug Class: Monoclonal Antibodies, Transplant Agents, Multiple Sclerosis Agents (https://livertox.nlm.nih.gov//MultipleSclerosisAgents.htm)

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Daclizumab – Zinbryta®

DRUG CLASS

Transplant Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?label=all&query=Daclizumab)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO. | MOLECULAR FORMULA | STRUCTURE
Daclizumab | 152923-56-3 | Monoclonal Antibody

## ANNOTATED BIBLIOGRAPHY

References updated: 10 December 2025

Reuben A. Hepatotoxicity of immunosuppressive drugs. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2011, pp. 569-91. (Review of hepatotoxicity of immunosuppressive agents mentions rituximab and problems of reactivation of hepatitis B, but also states that "the biological immunosuppressants are largely free from hepatotoxicity, with the exception of the TNF alpha antagonists").
Krensky AM, Azzi JR, Hafler DA. Immunotherapy for multiple sclerosis. Immunosuppressants and tolerogens. In, Brunton LL, Hilal-Dandan, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 649-652. (Textbook of pharmacology and therapeutics).
Vincenti F, Kirkman R, Light S, Bumgardner G, Pescovitz M, Halloran P, Neylan J, et al. Interleukin-2-receptor blockade with daclizumab to prevent acute rejection in renal transplantation. Daclizumab Triple Therapy Study Group. N Engl J Med 1998; 338: 161-5. (Among 260 patients undergoing renal transplantation treated with cyclosporine, azathioprine and prednisone with or without daclizumab, acute rejection was less common with daclizumab induction therapy [22% vs 35%] and there was no increase in opportunistic infections or adverse events; no mention of ALT elevations or hepatotoxicity). 9428817
New monoclonal antibodies to prevent transplant rejection. Med Lett Drugs Ther 1998; 40 (1036): 93-4. (Concise review of the efficacy and safety of basiliximab and daclizumab, two monoclonal antibodies to the IL2 receptor, shortly after their approval for use in transplantation in the US; no mention of ALT elevations or hepatotoxicity for either). 9774964
Heffron TG, Pillen T, Smallwood GA, Welch D, Oakley B, Romero R. Pediatric liver transplantation with daclizumab induction. Transplantation 2003; 75: 2040-3. (Among 81 children undergoing liver transplantation, the rate of acute rejection was lower with daclizumab induction therapy than without [15% vs 50%] and no adverse events were reported). 12829908
Nussenblatt RB, Thompson DJ, Li Z, Chan CC, Peterson JS, Robinson RR, Shames RS, et al. Humanized anti-interleukin-2 (IL-2) receptor alpha therapy: long-term results in uveitis patients and preliminary safety and activity data for establishing parameters for subcutaneous administration. J Autoimmune 2003; 21: 283-93. (Among 10 patients with severe uveitis treated with varying doses of daclizumab [every 2-6 weeks, intravenously or subcutaneously], 7 were maintained on therapy for 4 years, 2 of whom had minor transient serum ALT elevations which were considered only possibly related to the monoclonal antibody therapy). 14599854
Sellers MT, McGuire BM, Haustein SV, Bynon JS, Hunt SL, Eckhoff DE. Two-dose daclizumab induction therapy in 209 liver transplants: a single-center analysis. Transplantation 2004; 78: 1212-7. (Among 352 liver transplant recipients, the 209 who received daclizumab induction therapy had lower rates of acute rejection [25% vs 39%] and hepatitis C recurrent rates were similar; no mention of hepatotoxicity). 15502722
Morris JA, Hanson JE, Steffen BJ, Chu AH, Chi-Burris KS, Gotz VP, Gordon RD. Daclizumab is associated with decreased rejection and improved patient survival in renal transplant recipients. Clin Transplant 2005; 19 (3): 340-5. (Analysis of SRTR database on renal transplant recipients receiving daclizumab [n=8203] or no induction treatment [n=25368] in the US between 1998 and 2003 found lower reported rates of rejection with daclizumab [13% vs 17% after 3 years] and improved patient and graft survival, with no excess mortality from malignancy or opportunistic infections). 15877795
Rostaing L, Cantarovich D, Mourad G, Budde K, Rigotti P, Mariat C, Margreiter R, et al.; CARMEN Study Group. Corticosteroid-free immunosuppression with tacrolimus, mycophenolate mofetil, and daclizumab induction in renal transplantation. Transplantation 2005; 79: 807-14. (Among 538 renal transplant recipients followed for at least 6 months, there were no differences in rates of acute rejection, patient or graft survival or in overall safety between those given daclizumab induction therapy and corticosteroid avoidance or standard immunosuppressive treatment). 15818323
Mottershead M, Neuberger J. Daclizumab. Expert Opin Biol Ther 2007; 7: 1583-96. (Review of the mechanism of action, pharmacology, efficacy and safety of daclizumab; no mention or discussion of hepatotoxicity or ALT elevations). 17916050
Otero A, Varo E, de Urbina JO, Martín-Vivaldi R, Cuervas-Mons V, González-Pinto I, Rimola A, et al. A prospective randomized open study in liver transplant recipients: daclizumab, mycophenolate mofetil, and tacrolimus versus tacrolimus and steroids. Liver Transpl 2009; 15: 1542-52. (Among 157 patients underlying liver transplantation treated with induction therapy using daclizumab or a standard corticosteroid containing regimen, acute rejection was more frequent with standard therapy [27% vs 12% within 24 weeks], but patient and graft survival and rates of hepatitis C recurrence were similar). 19877219
Wynn D, Kaufman M, Montalban X, Vollmer T, Simon J, Elkins J, O'Neill G, et al.; CHOICE investigators. Daclizumab in active relapsing multiple sclerosis (CHOICE study): a phase 2, randomised, double-blind, placebo-controlled, add-on trial with interferon beta. Lancet Neurol 2010; 9: 381-90. (Among 230 patients with relapsing multiple sclerosis who were treated with beta interferon with or without daclizumab, "common adverse events were equally distributed across groups", but serious adverse events were more common in daclizumab treated subjects; no mention of ALT elevations or hepatotoxicity). 20163990
Kandus A, Arnol M, Omahen K, Oblak M, Vidan-Jeras B, Kmetec A, Bren AF. Basiliximab versus daclizumab combined with triple immunosuppression in deceased donor renal transplantation: a prospective, randomized study. Transplantation 2010; 89: 1022-7. (Among 212 patients given induction therapy before renal transplantation with either basiliximab or daclizumab, there were no differences in rates of rejection, graft or patient survival or adverse events; no mention of ALT elevations or hepatotoxicity). 20075788
Cai J, Terasaki PI. Induction immunosuppression improves long-term graft and patient outcome in organ transplantation: an analysis of United Network for Organ Sharing registry data. Transplantation 2010; 90: 1511-5. (Since 2003, most solid organ transplant recipients have received induction therapy, and analyses of the UNOS registry for this period shows highest rates of patient and graft survival with alemtuzumab [89% 5 year patient survival] as compared to antithymocyte globulin [89%], basiliximab [84%], daclizumab [77%], steroids [75%] or no induction [71%]). 21057388
Hanaway MJ, Woodle ES, Mulgaonkar S, Peddi VR, Kaufman DB, First MR, Croy R, et al. INTAC Study Group. Alemtuzumab induction in renal transplantation. N Engl J Med 2011; 364: 1909-19. (Among 474 patients undergoing renal transplantation and given alemtuzumab or convention induction therapy, acute rejection rates during the first 3 years were lower with alemtuzumab than basiliximab in low risk patients [15% vs 24%], but were similar with alemtuzumab and antithymocyte globulin in high risk patients [30% vs 24%]). 21591943
Klintmalm GB, Davis GL, Teperman L, Netto GJ, Washburn K, Rudich SM, Pomfret EA, et al. A randomized, multicenter study comparing steroid-free immunosuppression and standard immunosuppression for liver transplant recipients with chronic hepatitis C. Liver Transpl 2011; 17: 1394-403. (Among 295 patients undergoing liver transplantation for chronic hepatitis C treated with daclizumab, mycophenolate and tacrolimus or a corticosteroid-containing regimen without daclizumab, there were no differences between groups in graft or patient survival or in biochemical and histological severity of recurrent hepatitis C). 21850690
Wroblewski K, Sen HN, Yeh S, Faia L, Li Z, Sran P, Gangaputra S, et al. Long-term daclizumab therapy for the treatment of noninfectious ocular inflammatory disease. Can J Ophthalmol 2011; 46: 322-8. (Among 39 patients with chronic uveitis treated with daclizumab for an average of 40 months, skin toxicity was the most common adverse event, but did not prevent continuation of therapy; mentions elevated liver function tests, but no details given and no other mention of hepatotoxicity or discontinuations for liver toxicity). 21816251
Gold R, Giovannoni G, Selmaj K, Havrdova E, Montalban X, Radue EW, Stefoski D, et al.; SELECT study investigators. Daclizumab high-yield process in relapsing-remitting multiple sclerosis (SELECT): a randomised, double-blind, placebo-controlled trial. Lancet 2013; 381 (9884): 2167-75. (Among 621 patients with relapsing multiple sclerosis treated with daclizumab [150 or 300 mg] or placebo subcutaneously once weekly for 52 weeks, patients on daclizumab had fewer relapses, but rates of skin toxicity [18-22% vs 13%] and infections [50-54% vs 44%] were more common; rates of ALT elevations were similar [33-37% vs 34%], but were above 5 times ULN in 2% vs <1%). 23562009
Giovannoni G, Gold R, Selmaj K, Havrdova E, Montalban X, Radue EW, Stefoski D, et al.; SELECTION Study Investigators. Daclizumab high-yield process in relapsing-remitting multiple sclerosis (SELECTION): a multicentre, randomised, double-blind extension trial. Lancet Neurol 2014; 13: 472-81. PMID: (Among 517 patients with multiple sclerosis who participated in the SELECT trial [Gold 2013] and were enrolled in an extension study, one developed hepatitis after stopping and restarting daclizumab, ALT levels rising to 195 U/L after 8 weeks and 638 U/L at 12 weeks at which time serum bilirubin levels rose and symptoms of liver failure appeared, with increased IgG levels and liver histology at autopsy suggesting autoimmune hepatitis). 24656609
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52.e7. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 5 cases were attributed to monoclonal antibodies, but none to daclizumab). 25754159
https://www.accessdata.fda.gov/drugsatfda_docs/nda/2016/761029Orig1s000MedR.pdf (FDA medical review of daclizumab describing the hepatic adverse events observed in the preregistration trials in multiple sclerosis which included 7 cases [0.3%] of suspected autoimmune hepatitis including one death among the 2236 patients in the safety assessment).
Giovannoni G, Kappos L, Gold R, Khatri BO, Selmaj K, Umans K, Greenberg SJ, et al. Safety and tolerability profile of daclizumab in patients with relapsing-remitting multiple sclerosis: An integrated analysis of clinical studies. Mult Scler Relat Disord 2016; 9: 36-46. (Analysis of safety of daclizumab based upon six clinical studies and 2236 treated patients including ALT elevations at least 3 times ULN which occurred in 10% and were mostly asymptomatic and self-limiting, not recurring with continuation or restarting therapy, but accounting for drug discontinuation in 5% of subjects and qualifying as a serious adverse event in 1%). 27645341
Gold R, Radue EW, Giovannoni G, Selmaj K, Havrdova E, Stefoski D, Sprenger T, et al. Safety and efficacy of daclizumab in relapsing-remitting multiple sclerosis: 3-year results from the SELECTED open-label extension study. BMC Neurol 2016; 16: 117. (Among 410 patients with multiple sclerosis enrolled in an extension study of daclizumab with 854 patient-years of exposure, hepatic adverse events occurred in 15% that were serious in 1%; ALT or AST elevations above 3 times ULN occurred in 9%, above 5 times ULN in 4%, and 2 patients developed hepatitis with jaundice). 27461166
Daclizumab (Zinbryta) for multiple sclerosis. Med Lett Drugs Ther 2016; 58 (1503): 117-9. (Concise summary of the mechanism of action, clinical efficacy, safety and costs of daclizumab shortly after its approval for use in relapsing multiple sclerosis in the US; mentions that it has a black box warning regarding liver injury, that it is contraindicated in patients with liver disease, and that liver tests should be monitored monthly during treatment and 6 months after the last dose). 27603962
Herwerth M, Hemmer B. Daclizumab for the treatment of relapsing-remitting multiple sclerosis. Expert Opin Biol Ther 2017; 17: 747-53. (Review of the mechanism of action, clinical efficacy and safety of daclizumab as therapy of multiple sclerosis concludes that "given its substantial effectiveness, daclizumab can be an attractive option for patients with highly active MS"). 28286970
Risk of severe liver injury with daclizumab (Zinbryta). Drug Ther Bull 2017; 55: 110. (Warning on the risk of severe liver injury from daclizumab from the Medicines and Healthcare Products Regulatory Agency mentioning 4 cases under review). 28978627
McGinley MP, Moss BP, Cohen JA. Safety of monoclonal antibodies for the treatment of multiple sclerosis. Expert Opin Drug Saf. 2017;16:89-100.. (Review of the safety of 5 monoclonal antibodies used to treat multiple sclerosis, including natalizumab, alemtuzumab, daclizumab, rituximab, and ocrelizumab mentions that daclizumab was found to have a higher rate of serious adverse events than placebo in controlled trials and higher rates of ALT and AST elevations above 5 times ULN, and there was at least one death from an autoimmune hepatitis like fatal case) 27756172
Papadopoulou A, Derfuss T, Sprenger T. Daclizumab for the treatment of multiple sclerosis. Neurodegener Dis Manag. 2017;7:279-297.. (Review of the mechanism of action, pharmacology, efficacy and safety of daclizumab as therapy of multiple sclerosis, mentions that there have been two cases of fatal liver injury attributed to its use). 28849702
Krysko KM, Graves J, Rensel M, Weinstock-Guttman B, Aaen G, Benson L, Chitnis T, et al.; US Network of Pediatric MS Centers. Use of newer disease-modifying therapies in pediatric multiple sclerosis in the US. Neurology. 2018;91:e1778-e1787.. (In a cohort of 1019 children with multiple sclerosis from 12 outpatient practices followed for a mean of 3.5 years, 78% received at least one newer disease modifying agents including 5 on daclizumab, 1 of whom developed liver dysfunction). 30333163
Gold R, Radue EW, Giovannoni G, Selmaj K, Havrdova EK, Montalban X, Stefoski D, et al. Long-term safety and efficacy of daclizumab beta in relapsing-remitting multiple sclerosis: 6-year results from the SELECTED open-label extension study. J Neurol. 2020;267:2851-2864.. (Among 455 patients with multiple sclerosis enrolled in a placebo controlled trial of daclizumab, 410 agreed to enroll in an extension trial of 150 mg given subcutaneously every 4 weeks for up to 6 years, efficacy was maintained with annualized relapse rates of less than 0.2 but 45% of patients discontinued treatment including 22% because of adverse events, hepatic events being reported in 25% that were serious in 2% but none were fatal; ALT or AST elevations above 3 times ULN arose in 15%). 32451615
Kappos L, Cohan S, Arnold DL, Robinson RR, Holman J, Fam S, Parks B, et al. Safety and efficacy of daclizumab beta in patients with relapsing multiple sclerosis in a 5-year open-label study (EXTEND): final results following early termination. Ther Adv Neurol Disord. 2021;14:1756286420987941.. (Among 1203 patients with relapsing multiple sclerosis followed in an open-label extension study, 92% had at least one adverse event which were serious in 29% and led to discontinuation in 20% including 2% due to liver test abnormalities but there were no liver-related deaths.; ALT or AST elevations above 3 times ULN arose in 11%, above 5 times ULN in 7%, and above 10 times ULN in 3%). 33737954
Krämer J, Wiendl H. What have failed, interrupted, and withdrawn antibody therapies in multiple sclerosis taught us? Neurotherapeutics. 2022;19:785-807.. (Analysis of monoclonal antibodies that appeared to be beneficial in multiple sclerosis in preclinical and early clinical studies that ultimately proven to be poorly effective or too toxic in subsequent studies, discusses the history of development, clinical evaluation, and ultimate withdrawal of daclizumab which was largely due to a high rate of hepatic adverse events and two cases of fatal liver injury). 35794296
Bessone F, Hernandez N, Medina-Caliz I, García-Cortés M, Schinoni MI, Mendizabal M, Chiodi D, et al. Drug-induced liver injury in Latin America: 10-year experience of the Latin American DILI (LATINDILI) Network. Clin Gastroenterol Hepatol. 2025;23:89-102.. (Among 483 cases of drug-induced liver injury enrolled in a prospective Latin American database, one case was attributed to fingolimod and one to natalizumab, but no other agents used to treat multiple sclerosis were listed: personal communication). 38992407

## OTHER REFERENCE LINKS

1. Recent References on Daclizumab: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Daclizumab+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))

2. Trials on Daclizumab: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Daclizumab)

3. TOXLINE Citations on Daclizumab: from PubMed.gov (https://toxnet.nlm.nih.gov/cgi-bin/sis/search/r?dbs+toxline:%40and+Daclizumab+%40rel+(cholestasis+hepatocellular+jaundice+hepatitis+steatosis+transaminase+%22liver+disease%22+%22liver+function%22+%22autoimmune+reaction%22)+%40not+%40org+pubmed+%40not+%40org+pubdart)